# Benznidazole

## OVERVIEW

### Introduction

Benznidazole is an orally available, broad spectrum antimicrobial agent used in the treatment of Chagas disease (American trypanosomiasis). Benznidazole is a nitroimidazole similar to metronidazole and is associated with serum enzyme elevations during therapy in up to 10% of patients but has not linked to cases of clinically apparent acute liver injury.

### Background

Benznidazole (benz nid' a zole) is an oral, broad spectrum nitroimidazole antimicrobial that has activity against bacteria as well as several parasites. Like other nitroimidazoles such as metronidazole, benznidazole is activated intracellularly by bacterial or parasitic enzymes to a radical anion, which damages large protein molecules and DNA. Benznidazole has been found to be particularly effective against Trypanosoma cruzi, the cause of Chagas disease (American trypanosomiasis). In multiple clinical studies in both children and adults, with congenital, acute and chronic Chagas disease, a course of benznidazole has resulted in a high rate of cure. Chronic Chagas disease can lead to morbidity and mortality from digestive and cardiac disease and is endemic in much of Latin America. With increasing rates of emigration, Chagas disease has become a global problem and there are an estimated 300,000 persons with Chagas disease living in the United States. In 2017, benznidazole became the first agent to receive FDA approval as therapy for Chagas disease while nifurtimox became in second in 2020. Current indications for benznidazole are limited to children with Chagas disease ages 2 to 12 years. Benznidazole is available generically in tablets of 12.5 and 100 mg, and the recommended dose is 5 to 8 mg/kg orally in two divided doses daily for 60 days. Common side effects include abdominal pain, anorexia, weight loss, nausea, vomiting, headache, rash, urticaria and pruritus. Less common but potentially severe adverse reactions include hypersensitivity skin reactions, DRESS syndrome, peripheral neuropathy, bone marrow suppression, neutropenia, thrombocytopenia, anemia, carcinogenicity, genotoxicity and embryo-fetal toxicity.

### Hepatotoxicity

Benznidazole therapy is associated with an appreciable rate of serum enzyme elevations, found in at least 10% of patients. The abnormalities, however, are generally mild, transient and without accompanying symptoms or jaundice. In clinical trials there were no reported instances of clinically apparent liver injury with jaundice attributed to benznidazole. However, since its approval and more widescale use, there have been several case reports of drug rash with eosinophilia and systemic symptoms (DRESS syndrome) accompanied by serum enzyme elevations associated with benznidazole therapy, one of which was accompanied by jaundice. Furthermore, cases of immunoallergic hepatitis have been reported with other more commonly used nitroimidazoles such as metronidazole and ornidazole, some of which have been severe. Thus, benznidazole therapy has had limited clinical use, but it appears to have the potential to cause symptomatic, immunoallergic hepatitis with jaundice.

Likelihood score: D (possible rare cause of clinically apparent liver injury, usually as a component of DRESS syndrome).

### Mechanism of Injury

The cause of the serum enzyme elevations during benznidazole therapy is unknown. Benznidazole is metabolized in the liver where it undergoes glucuronidation but has not been found to lead to significant drug-drug interactions.

### Outcome and Management

The severity of the liver injury linked to benznidazole therapy has been mild and self-limited, usually with transient, asymptomatic serum enzyme elevations, occasionally accompanied by hypersensitivity reactions or jaundice. However, the use of benznidazole has been limited. In instances of allergic reactions or anaphylaxis, benznidazole should be discontinued and rechallenge should be avoided. There is no information on whether there is cross sensitivity to hypersensitivity reactions or hepatic injury between benznidazole and other nitroimidazoles.

Drug Class: Antiinfective Agents, Trypanosomiasis Agents

Other Drugs in the Subclass, Nitroimidazoles: Fexinidazole, Metronidazole, Secnidazole, Tinidazole

Other Trypanosomiasis Agents: Fexinidazole, Nifurtimox

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Benznidazole – Generic

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=8983d6a0-f63f-4f8e-bba4-38223f39e29b)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Benznidazole | 22994-85-0 | C12-H12-N4-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2023

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 589-637. (Expert review of hepatotoxicity of antibiotics published in 1999; does not mention benznidazole).
Moseley RH. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013, p. 463-81. (Review of hepatotoxicity of antibacterial medications; does not discuss benznidazole).
Wetzel DM, Phillips MA. Chemotherapy of protozoal infections. In, Brunton LL, Halil-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 987-1000. (Textbook of pharmacology and therapeutics).
Rosenthal PJ. Antiprotozoal drugs. In, Katzung BG, Masters SB, Trevor AJ. Basic and clinical pharmacology. 12th ed. New York: McGraw Hill, 2012, pp. 934. (Textbook of pharmacology and therapeutics mentions that benznidazole has activity similar to nifurtimox, the most frequently used drug for Chagas disease).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/209570Orig1s000SumR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that ALT or AST elevations “were noted in all studies submitted for review” but were all transient and mostly mild and none were accompanied by jaundice).
CDC. Parasites - American trypanosomiasis (also known as Chagas disease). Available at: https://www.cdc.gov/parasites/chagas/ (CDC website on American trypanosomiasis provides up-to-date information on epidemiology, diagnosis, clinical features, complications and therapy of Chagas disease and resources for obtaining nifurtimox and benznidazole).
Roe FJ. Safety of nitroimidazoles. Scand J Infect Dis Suppl 1985; 46: 72-81. (Review of the safety of the nitroimidazoles mentions that common side effects are nausea, headaches, metallic taste, furred tongue, itching and skin rash and occasional transient elevations in serum aminotransferase levels). 3865353
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to a nitroimidazole antibiotic). 20949552
Hasslocher-Moreno AM, do Brasil PE, de Sousa AS, Xavier SS, Chambela MC, Sperandio da Silva GM. Safety of benznidazole use in the treatment of chronic Chagas' disease. J Antimicrob Chemother 2012; 67: 1261-6. (Among 190 patients with chronic Chagas disease, ages 13 to 65 years, treated with benznidazole for 4-180 days, adverse events occurred in 49%, were severe in 0.5% and resulted in drug discontinuation in 15% of subjects, the major cause being skin reactions; no mention of ALT elevations or hepatotoxicity). 22331592
Molina I, Gómez i Prat J, Salvador F, Treviño B, Sulleiro E, Serre N, et al. Randomized trial of posaconazole and benznidazole for chronic Chagas' disease. N Engl J Med 2014; 370: 1899-908. (Among 78 adults with chronic Chagas disease treated with benznidazole or posaconazole for 60 days, long term eradication of detectable parasites occurred in greater proportion of benznidazole recipients [62% vs 8-19%], while adverse events were less, including ALT elevations [20% vs 47%], ALT values above 5 times ULN occurring only in subjects on posaconazole). 24827034
Morillo CA, Marin-Neto JA, Avezum A, Sosa-Estani S, Rassi A Jr, Rosas F, Villena E, et al.; BENEFIT Investigators. Randomized trial of benznidazole for chronic Chagas' cardiomyopathy. N Engl J Med 2015; 373: 1295-306. (Among 2854 South American patients with Chagas cardiomyopathy treated with benznidazole or placebo for up to 80 days, rates of parasite eradication were higher with treatment [66% vs 39.5%], but long term cardiac morbidity and mortality were not different; adverse events during treatment included skin reactions [9.6% vs 1.3%], gastrointestinal reactions [7.8% vs 2.9%] and peripheral neuropathy [3.6% vs 1.3%]; no mention of ALT elevations or hepatotoxicity). 26323937
Bern C. Chagas' disease. N Engl J Med 2015; 373 (5): 456-66. (Review of the parasite life cycle, modes of transmission, epidemiology, clinical features, complications, diagnosis and treatment of Chagas disease; mentions that the most frequent side effect of benznidazole therapy is skin rash which, if accompanied by fever or lymphadenopathy, should lead to immediate discontinuation). 26222561
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to metronidazole or other nitroimidazoles). 25754159
Blumenthal KG, Youngster I, Rabideau DJ, Parker RA, Manning KS, Walensky RP, Nelson SB. Peripheral blood eosinophilia and hypersensitivity reactions among patients receiving outpatient parenteral antibiotics. J Allergy Clin Immunol 2015; 136: 1288-94.e1. (Among 824 patients receiving outpatient parenteral antibiotic therapy who had concurrent white blood cell and differential counts, eosinophilia [>500 cells/uL] was found in 25%, being most common with vancomycin [30%], the penicillins [28%], carbapenems [28%], cephalosporins [22%], fluoroquinolones [21%], and less common with metronidazole [15%], and there was no association of eosinophilia with liver test abnormalities). 25981739
Manne-Goehler J, Umeh CA, Montgomery SP, Wirtz VJ. Estimating the burden of Chagas disease in the United States. PLoS Negl Trop Dis 2016; 10: e0005033. (Based upon rates of foreign born Hispanics in the population, there are 238,091 cases of Chagas disease in the US [largely unrecognized] and possibly another 109,000 among undocumented immigrants). 27820837
Sperandio da Silva GM, Mediano MFF, Hasslocher-Moreno AM, Holanda MT, Silvestre de Sousa A, Sangenis LHC, Brasil PEAAD, et al. Benznidazole treatment safety: the Médecins Sans Frontières experience in a large cohort of Bolivian patients with Chagas' disease. J Antimicrob Chemother 2017; 72: 2596-601. (Among 2075 patients with Chagas disease treated with benznidazole in programs run by Doctors without Borders in Brazil, 56% had adverse events which were severe in 2 [0.1%] and resulted in discontinuation in 344 [16.5%], most of which were dermatologic reactions and 45% of whom were able to restart and finish therapy; no mention of ALT elevations or hepatotoxicity). 28645201
Olivera MJ, Cucunubá ZM, Valencia-Hernández CA, Herazo R, Agreda-Rudenko D, Flórez C, Duque S, et al. Risk factors for treatment interruption and severe adverse effects to benznidazole in adult patients with Chagas disease. PLoS One 2017; 12: e0185033. (Among 224 adults with Chagas disease treated with a 60 day course of benznidazole, side effects were common [91%] including rash [38%], itching [34%], abdominal pain [26%], bloating [24%] and nausea [27%], leading to early discontinuation in 23% of patients; eosinophilia arose in 9%, and DRESS in 21%, while ALT or AST were elevated in 2% of patients, but all adverse events resolved upon stopping). 28949997
Cardoso CS, Ribeiro ALP, Oliveira CDL, Oliveira LC, Ferreira AM, Bierrenbach AL, Silva JLP, et al. Beneficial effects of benznidazole in Chagas disease: NIH SaMi-Trop cohort study. PLoS Negl Trop Dis 2018; 12: e0006814. (Among 1813 Brazilian patients with Chagas disease and abnormal electrocardiograms who were followed for at least 2 years, the mortality rate was lower in the 493 who had received at least one course of benznidazole than in those who did not [2.8% vs 7.8%] as were rates of parasitemia [17% vs 36%] and EKG abnormalities [48% vs 60%]; no mention of ALT elevations or hepatotoxicity). 30383777
Pavan TBS, Silva JWD, Martins LC, Costa SCB, Almeida EA. Hepatic changes by benznidazole in a specific treatment for Chagas disease. PLoS One 2018; 13: e0200707. (Among 204 patients with Chagas disease [7% acute, 93% chronic] treated with benznidazole, 48 [24%] had skin rash and 35 [17%] had serum enzyme elevations [peak ALT 310 U/L, AST 220 U/L, Alk P 302 U/L and GGT 258 U/L]; no mention of jaundice or outcome of the abnormalities). 30028842
Moreno-Escobosa C, Cruz-Granados S. Drug reaction with eosinophilia and systemic symptoms syndrome induced by benznidazole. Contact Dermatitis 2018; 79: 105-6. (30 year old Bolivian woman with chronic Chagas disease developed fever, rash, eosinophilia and serum ALT elevations [103 U/L] 50 days after starting benznidazole and while also receiving cloxacillin, naproxen and dipyrone). 29635801
Meymandi S, Hernandez S, Park S, Sanchez DR, Forsyth C. Treatment of Chagas disease in the United States. Curr Treat Options Infect Dis 2018; 10: 373-88. (Review of the epidemiology, clinical features, diagnosis, complications and therapy of Chagas disease as seen in the US; mentions that reported response rates to benznidazole are 96% for congenital, 76% for acute, 62% of chronic infection in children and 37% for chronic infection in adults; recommends routine liver tests before starting therapy and regular monitoring during treatment). 30220883
Crespillo-Andújar C, Venanzi-Rullo E, López-Vélez R, Monge-Maillo B, Norman F, López-Polín A, Pérez-Molina JA. Safety profile of benznidazole in the treatment of chronic Chagas disease: experience of a referral centre and systematic literature review with meta-analysis. Drug Saf 2018; 41: 1035-48. (Systematic review of 42 studies [7822 patients] of safety of benznidazole in Chagas disease found overall rate of adverse events of 44% but range of 0-98% and while there was no mention of specific symptoms or ALT elevations, serious adverse events mentioned included “toxic hepatitis” without further details). 30006773
Ataee P, Karimi A, Eftekhari K. Hepatic failure following metronidazole in children with Cockayne syndrome. Case Rep Pediatr 2020; 2020: 9634196. (Two cases: 2 and 5 years old, both boys with type B [infant onset] Cockayne syndrome developed jaundice, vomiting and agitation 2 and 3 days after starting oral metronidazole for minor infection [bilirubin 13.7 and 16.0 mg/dL, ALT 2815 and 2248 U/L, Alk P 1265 and 1654 U/L, INR 5.1 and 4.6], one dying within 2 days of admission and the second recovering but with persistent jaundice and serum enzyme elevations one month later; whether benznidazole might cause similar injury is not known). 32082677
Giancola ML, Corpolongo A, Comandini UV, Del Nonno F, Montalbano M, Petrone A, Carrara S, et al. Severe drug-induced liver injury (DILI) associated with benznidazole therapy for Chagas' disease. J Antimicrob Chemother. 2022;77:3515-3517. (68 year old woman with chronic indeterminate Chagas disease developed rash 3 weeks after starting benznidazole with elevations in ALT [178 rising to 594 U/L], but normal bilirubin and alkaline phosphatase levels at 5 weeks when benznidazole was stopped and she was treated with high dose methylprednisolone and 2-3 weeks later had further rise in liver test abnormalities [ALT 3170 U/L, bilirubin 4.1 mg/dL], which resolved spontaneously over the next month). 36173378

## OTHER REFERENCE LINKS

1 Recent References on Benznidazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(benznidazole/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))
2 Trials on Benznidazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?cond=&term=Benznidazole&cntry=&state=&city=&dist=)